# Deferasirox

## OVERVIEW

### Introduction

Deferasirox is an oral iron chelating agent used to treat chronic iron overload. Deferasirox has been linked to a low rate of transient serum aminotransferase elevations during therapy and to rare instances of clinically apparent liver injury, which can be severe and even fatal.

### Background

Deferasirox (dee fer’ a sir ox) is an orally available iron chelating agent that is selective for ferric iron and binds iron with a high affinity. Deferasirox binds two iron molecules and is eliminated in the feces after hepatic metabolism by glucuronidation. Deferasirox also binds zinc and copper, but to a far lower extent than iron. In clinical trials in patients with transfusion related iron overload, deferasirox lowered both circulating and tissue (cardiac, liver) iron. Deferasirox was approved for use in the United States in 2005 and current indications are for chronic iron overload due to blood transfusion and in nontransfusion dependent thalassemia syndromes. Deferasirox is available in tablets of 125, 250 and 500 mg under the brand name Exjade. The recommended initial dose is 10 to 20 mg/kg daily. Side effects can include diarrhea, nausea, abdominal pain, headache, dizziness, rash and increases in serum creatinine. Uncommon, but potentially severe adverse events are renal failure, gastrointestinal bleeding, bone marrow suppression and hypersensitivity reactions including Stevens Johnson syndrome.

### Hepatotoxicity

In large clinical trials of deferasirox, elevations in serum aminotransferase levels above 5 times the upper limit of normal (ULN) occurred in 6% of patients and led to drug discontinuation in 1% to 2%. In addition, there have been several single case reports of clinically apparent liver injury arising during deferasirox therapy which was often severe and occasionally fatal. The onset of acute liver injury ranged from a few days to severak years after starting deferasirox but most cases occurred within 1 to 3 months. The pattern of liver injury was typically hepatocellular or mixed with prominent elevations in serum aminotransferase levels. Immunoallergic and autoimmune features were absent. Recovery was usually rapid once deferasirox was stopped, but some cases were associated with progressive liver injury and hepatic failure. Because patients with iron overload often have underlying liver disease, a superimposed acute hepatocellular injury may result in an increased risk of acute liver failure. Deferasirox has a boxed warning regarding hepatotoxicity and regular monitoring of serum bilirubin and aminotransferase levels is recommended.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during deferasirox therapy is not known. The injury may be due to direct, intrinsic toxicity and to have a more severe outcome in patients with pre-existing liver disease as a result of iron overload or concurrent hepatitis B or C. Deferasirox is metabolized in the liver largely by glucuronidation and biliary excretion. At least one case of severe liver injury attributed to deferasirox was associated with polymorphisms of the hepatic genes known to be involved in deferasirox excretion.

### Outcome and Management

Deferasirox is well known to cause transient serum aminotransferase elevations that are usually self-limited and benign. However, it has also been implicated in cases of clinically apparent liver injury and acute liver failure.. The product label recommends monitoring of serum aminotransferase levels and bilirubin before and every 2 weeks for the first month of treatment, followed by at least monthly thereafter. Persistent serum aminotransferase elevations and values above 5 times ULN should lead to dose reduction or temporary cessation. There does not appear to be cross reactivity in risk for hepatic injury between deferasirox and other chelators including deferoxamine or deferiprone.

Drug Class: Hematological Agents; Chelating Agents, Iron Chelators

Other Drugs in the Subclass, Iron Chelators: Deferiprone, Deferoxamine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Deferasirox – Exjade®

DRUG CLASS

Hematological Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Deferasirox)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Deferasirox | 201530-41-8 | C21-H15-N3-O4 | Deferasirox structure

## ANNOTATED BIBLIOGRAPHY

References updated: 26 December 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of deferasirox).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; iron chelating agents are not discussed).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1872-6. (Textbook of pharmacology and therapeutics).
Deferasirox (Exjade): a new iron chelator. Med Lett Drugs Ther 2006; 48 (1233): 35-6. (Concise review of the efficacy, safety and costs of deferasirox mentions that it has been associated with serum aminotransferase elevations and several cases of hepatitis). 16625144
Cappellini MD, Cohen A, Piga A, Bejaoui M, Perrotta S, Agaoglu L, Aydinok Y, et al. A phase 3 study of deferasirox (ICL670), a once-daily oral iron chelator, in patients with beta-thalassemia. Blood 2006; 107: 3455-62. (Among 586 patients with beta thalassemia treated with either oral deferasirox or subcutaneous deferoxamine for one year, decreases in liver iron concentrations were similar with the highest doses; side effects of deferasirox included elevations in creatinine in 38% and ALT [ ≥2 times ULN] in two patients). 16352812
Galanello R, Piga A, Forni GL, Bertrand Y, Foschini ML, Bordone E, Leoni G, et al. Phase II clinical evaluation of deferasirox, a once-daily oral chelating agent, in pediatric patients with beta-thalassemia major. Haematologica 2006; 91: 1343-51. (Among 40 children [ages 2-17 years] with beta thalassemia major treated with deferasirox for 48 weeks, liver iron concentrations increased gradually despite treatment, and 5 subjects developed ALT or AST elevations ≥5 times ULN, which resolved on stopping and did not recur on restarting deferasirox). 17018383
Vichinsky E, Onyekwere O, Porter J, Swerdlow P, Eckman J, Lane P, Files B, et al.; Deferasirox in Sickle Cell Investigators. A randomised comparison of deferasirox versus deferoxamine for the treatment of transfusional iron overload in sickle cell disease. Br J Haematol 2007; 136: 501-8. (Among 195 adults with sickle cell disease and iron overload treated with either deferasirox or deferoxamine for 1 year, both groups had similar decreases in liver iron concentration, while ALT elevations ≥5 times ULN occurred in none on deferoxamine vs 5 [4%] on deferasirox, resolving despite continuing therapy in 4, but recurring with reexposure in 1 patient). 17233848
Cappellini MD. Long-term efficacy and safety of deferasirox. Blood Rev 2008; 22 Suppl 2: S35-41. (Review of the efficacy and safety of deferasirox, mentions that reversible elevations in serum aminotransferase levels occur in some patients). 19059055
Taher A, El-Beshlawy A, Elalfy MS, Al Zir K, Daar S, Habr D, Kriemler-Krahn U, et al. Efficacy and safety of deferasirox, an oral iron chelator, in heavily iron-overloaded patients with beta-thalassaemia: the ESCALATOR study. Eur J Haematol 2009; 82: 458-65. (In an open label study of deferasirox in 237 patients with beta thalassemia and iron overload, ALT elevations occurred in 5.5% of patients, but most resolved without need for discontinuation). 19187278
Gattermann N, Finelli C, Porta MD, Fenaux P, Ganser A, Guerci-Bresler A, Schmid M, et al.; EPIC study investigators. Deferasirox in iron-overloaded patients with transfusion-dependent myelodysplastic syndromes: Results from the large 1-year EPIC study. Leuk Res 2010; 34: 1143-50. (Among 341 patients with myelodysplastic syndromes and iron overload treated with deferasirox for up to one year, serum ALT and ferritin levels decreased together; one patient had an increase in ALT levels from 28 U/L before therapy to 568 U/L at day 190, with no information on symptoms, Alk P, bilirubin or long term outcome). 20451251
Phatak P, Brissot P, Wurster M, Adams PC, Bonkovsky HL, Gross J, Malfertheiner P, et al. A phase 1/2, dose-escalation trial of deferasirox for the treatment of iron overload in HFE-related hereditary hemochromatosis. Hepatology 2010; 52: 1671-779. (Among 49 patients with hemochromatosis treated with deferasirox for 48 weeks, ALT levels rose ≥3 times ULN in 16% and ≥5 times ULN in 10% of patients, but largely among those who received the highest dose [15 mg/kg/day]). 20814896
Aslam N, Mettu P, Marsano-Obando LS, Martin A. Deferasirox induced liver injury in haemochromatosis. J Coll Physicians Surg Pak 2010; 20: 551-3. (63 year old woman with hemochromatosis developed fatigue and dark urine one month after starting deferasirox [bilirubin 13.2 mg/dL, ALT 115 U/L, Alk P 395 U/L], improving slowly after stopping). 20688025
Imran FS, Phatak P. Deferasirox induced liver injury in haemochromatosis. J Coll Physicians Surg Pak 2011; 21: 718; author reply 718. (Letter in response to Aslam [2010] suggesting that the liver injury was due to the high dose used [~20 mg/kg]). 22078360
Cappellini MD, Bejaoui M, Agaoglu L, Canatan D, Capra M, Cohen A, Drelichman G, et al. Iron chelation with deferasirox in adult and pediatric patients with thalassemia major: efficacy and safety during 5 years' follow-up. Blood 2011; 118: 884-93. (Among 555 patients with thalassemia continued on deferasirox for up to 5 years after participation in a controlled trial [Cappellini 2008], liver iron concentrations decreased in those treated with the higher doses [20 and 30 mg/kg/day] and side effects were less with longer duration of therapy, ALT elevations ≥10 times ULN occurring in 1% of patients, but no mention of clinically apparent liver injury). 21628399
Vichinsky E, Bernaudin F, Forni GL, Gardner R, Hassell K, Heeney MM, Inusa B, et al. Long-term safety and efficacy of deferasirox (Exjade) for up to 5 years in transfusional iron-overloaded patients with sickle cell disease. Br J Haematol 2011; 154: 387-97. (Among 185 patients with sickle cell anemia and iron overload continued on deferasirox for up to 5 years after participation in a controlled trial [Vichinsky 2007], 5 [2.7%] had ALT elevations ≥5 times ULN, 2 more had elevations ≥10 times ULN, and one patient with chronic hepatitis C and cirrhosis underwent liver transplantation). 21592110
Sinakos E, Vlachaki E, Tsapas A. Safety of deferasirox in sickle cell disease patients with co-existing liver impairment. Br J Haematol 2012; 157: 505-6; author reply 506-7. (Letter in response to Vichinsky [2011] requesting further information on the patient with hepatitis C who died; the authors reply that the patient had anti-HCV, but was HCV RNA negative [suggesting that the liver disease was not due to hepatitis C]). 22299817
Vichinsky E, Torres M, Minniti CP, Barrette S, Habr D, Zhang Y, Files B; study CICL670A2201 investigators. Efficacy and safety of deferasirox compared with deferoxamine in sickle cell disease: two-year results including pharmacokinetics and concomitant hydroxyurea. Am J Hematol 2013; 88: 1068-73. (Among 203 patients with sickle cell disease and iron overload treated with deferasirox or deferoxamine for 6 months and then all were given deferasirox for 2 more years, ALT increases occurred in 9 [6%], which were ≥5 times ULN in 2 [1.5%] deferasirox vs none of deferoxamine treated subjects). 23946212
Kontoghiorghes GJ. A record number of fatalities in many categories of patients treated with deferasirox: loopholes in regulatory and marketing procedures undermine patient safety and misguide public funds? Author's response. Expert Opin Drug Saf 2013; 12: 794-5. (Editorial stating that there were 4113 fatalities among patients being treated with deferasirox in 2012 according to an anonymous postmarketing surveillance source, and that many patients who were being treated did not have iron overload). 24137699
Riva A. A record number of fatalities in many categories of patients treated with deferasirox: loopholes in regulatory and marketing procedures undermine patient safety and misguide public funds? Expert Opin Drug Saf 2013; 12: 793-4. (Letter in response to Kontoghiorghes [2013] from the sponsor of deferasirox claiming that the editorial had many factual inaccuracies). 23931143
Xia S, Zhang W, Huang L, Jiang H. Comparative efficacy and safety of deferoxamine, deferiprone and deferasirox on severe thalassemia: a meta-analysis of 16 randomized controlled trials. PLoS One 2013; 8: e82662. (Systematic review and metaanalysis of 16 publications comparing iron chelating agents found differences in myocardial content, but not "live iron" concentrations with different therapies and that the combination of deferoxamine and deferiprone had "higher risk" than deferoxamine). 24376563
Huang WF, Chou HC, Tsai YW, Hsiao FY. Safety of deferasirox: a retrospective cohort study on the risks of gastrointestinal, liver and renal events. Pharmacoepidemiol Drug Saf 2014; 23: 1176-82. (Retrospective analysis of a Taiwanese health database found that first time users of deferasirox had higher crude rates of acute liver necrosis than those on deferoxamine [2 of 133 vs 21 of 3507 patients: 0.26 vs 0.05 per 10,000 patient days], yet the differences in rates were not statistically significant). 24946110
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were chelating agents such as deferoxamine, deferiprone or deferasirox). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no case was attributed to deferoxamine or deferiprone, but 1 was due to deferasirox, a 54 year old woman with hemochromatosis who developed ALT elevations [rising from 25 to 305 U/L] without symptoms or jaundice a month after starting deferasirox that resolved rapidly with stopping and recurred upon restarting). 25754159
Ling G, Pinsk V, Golan-Tripto I, Ling E. Acute liver failure in a pediatric patient with congenital dyserythropoietic anemia type I treated with deferasirox. Hematol Rep 2015; 7: 5987. (12 year old female with congenital anemia and iron overload developed jaundice 3 months after starting oral deferasirox [bilirubin 11.3 rising to 21 mg/dL, ALT 345 U/L, GGT 376 U/L, INR 2.03], with recovery within a month of stopping deferasirox and treatment with N-acetyl cysteine [NAC]). 26487935
Ramaswami A, Rosen DJ, Chu J, Wistinghausen B, Arnon R. Fulminant liver failure in a child with β-thalassemia on deferasirox: a case report. J Pediatr Hematol Oncol 2017; 39: 235-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27479018) (3 year old female with beta-thalassemia on deferasirox for 1 year developed cough and fever with abnormal liver tests [bilirubin 2.2 mg/dL, ALT 199 U/L, GGT 40 U/L, INR 2.9] and rapidly developed respiratory failure, shock, lactic acidosis and died).
Botzenhardt S, Li N, Chan EW, Sing CW, Wong IC, Neubert A. Safety profiles of iron chelators in young patients with haemoglobinopathies. Eur J Haematol 2017; 98: 198-217. (Review of literature on safety of iron chelators in young patients reported "increased liver enzymes in 4% of subjects on deferoxamine, 6% on deferiprone and 20% on deferasirox; no mention of clinically apparent liver injury). 27893170
Menaker N, Halligan K, Shur N, Paige J, Hickling M, Nepo A, Weintraub L. Acute liver failure during deferasirox chelation: a toxicity worth considering. J Pediatr Hematol Oncol 2017; 39: 217-22. (12 year old male with sickle cell anemia and hemosiderosis on long term deferasirox [6 years] developed persistently elevated ALT levels [rising from 25 to 118-242 U/L] and then was found unresponsive, with subsequent liver and renal failure [peak bilirubin 19.6 mg/dL, ALT 379 U/L, AST 1076 U/L, CK 17205 U/L, protime 21.7 sec], with rapid recovery upon stopping deferasirox and eventual return of liver tests to baseline levels). 28221265
Parakh N, Chandra J, Sharma S, Dhingra B, Jain R, Mahto D. Efficacy and safety of combined oral chelation with deferiprone and deferasirox in children with β-thalassemia major: an experience from North India. J Pediatr Hematol Oncol 2017; 39: 209-13. (Among 33 children with beta-thalassemia and iron overload being treated with deferiprone or deferasirox who were then placed on both agents, 27% developed ALT or AST elevations above twice normal, which were usually transient and self-limited or responded to dose reduction of deferasirox). 28221264
Braga CCB, Benites BD, de Albuquerque DM, Alvarez MC, Seva-Pereira T, Duarte BKL, Costa FF, et al. Deferasirox associated with liver failure and death in a sickle cell anemia patient homozygous for the -1774delG polymorphism in the Abcc2 gene. Clin Case Rep 2017; 5: 1218-21. (43 year old woman with sickle cell anemia and iron overload, developed ALT elevations within a few weeks of starting deferasirox which continued to rise despite stopping treatment, with subsequent jaundice, coagulopathy, hepatic failure and death, genetic testing demonstrating homozygosity for a polymorphism in Abcc2, a known transporter of deferasirox). 28781827
Vichinsky E, El-Beshlawy A, Al Zoebie A, Kamdem A, Koussa S, Chotsampancharoen T, Bruederle A, et al. Long-term safety and efficacy of deferasirox in young pediatric patients with transfusional hemosiderosis: Results from a 5-year observational study (ENTRUST). Pediatr Blood Cancer 2017; 64. (Among 267 children [ages 2-6] with transfusional iron overload treated for up to 5 years with oral deferasirox, 31 [12%] had dose adjustments because of ALT elevations which were above 5 times ULN on 2 occasions in 9 [4%], but none developed clinically apparent liver injury with jaundice). 28296163
Osborne V, Davies M, Layton D, Shakir SAW. Utilisation and safety of deferasirox: results from an observational cohort study in England. Drug Saf 2017. [Epub ahead of print] (Among 122 patients who received prescriptions for deferasirox in a general practice setting in England between 2006 and 2014, liver injury and ALT elevations were not mentioned in summaries of adverse event reports and reasons for discontinuation). 29019038

## OTHER REFERENCE LINKS

1. Recent References on Deferasirox: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Deferasirox+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Deferasirox: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Deferasirox)